# Goserelin

## OVERVIEW

### Introduction

Goserelin is a parenterally administered, gonadotropin releasing hormone (GnRH) agonist which causes an inhibition of estrogen and androgen production and is used predominantly to treat prostate cancer. Goserelin has been associated with a modest rate of serum enzyme elevations during therapy, but has not been convincingly linked to instances of clinically apparent acute liver injury.

### Background

Goserelin (goe" se rel' in) is a synthetic decapeptide analogue of gonadotropin releasing hormone that acts as a partial agonist of the gonadotropin receptors in the pituitary that regulate luteinizing hormone (LH) and follicle stimulating hormone (FSH) secretion. These gonadotropins cause production and secretion of testosterone by the male testes and estrogen by the female ovaries. The continued receptor occupancy by goserelin, however, ultimately causes a down-regulation of production of LH and FSH and a resultant decrease in testosterone and estrogen levels. Goserelin, alone or in combination with other antiandrogens, has been found to be palliative in advanced prostate cancer. Goserelin was approved for use in the United States in 1989 and is still widely used, being considered important adjuvant therapy in management of advanced prostate cancer. Goserelin is also approved for use in advanced breast cancer and for several hormonally sensitive benign conditions such as endometriosis. The GnRH agonists have also been used off label for precocious puberty, infertility, and as a part of gender affirming therapy. Goserelin is available under the brand name Zoladex in solution for administration subcutaneously as implants every 4 (3.6 mg) or 12 (10.8 mg) weeks. Goserelin and the other GnRH analogues cause a profound hypogonadism ("chemical castration") and its common side effects are typical of androgen deprivation, including hot flashes, loss of libido, erectile dysfunction, depression, nausea, diarrhea, weight gain and fluid retention. Rare, but potentially severe adverse events can include immediate hypersensitivity reactions, pituitary apoplexy and, with long term use, weight gain, metabolic changes, diabetes and osteoporosis.

### Hepatotoxicity

Goserelin has been associated with mild serum enzyme elevations during therapy in 3% to 5% of patients, but values above 3 times the upper limit of normal are rare, being reported in less than 1% of recipients. The serum enzyme elevations during goserelin therapy have generally been transient and asymptomatic, resolving even with drug continuation and rarely requiring dose modification or discontinuation. Despite use for several decades, goserelin has been linked to only a single, and not entirely convincing, case of clinically apparent liver injury. Routine monitoring of patients for liver test abnormalities is not recommended.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver test abnormalities during goserelin therapy is not known. Goserelin is a short peptide and is metabolized locally in many tissues. It is not metabolized to an appreciable extent by the hepatic cytochrome P450 system and has not been associated with significant drug-drug interactions. Some serum enzyme elevations may be caused by nonalcoholic fatty liver arising because of weight gain or metabolic changes caused by the androgen deprivation state induced by the GnRH agonist.

### Outcome and Management

The serum enzyme elevations that occur on goserelin therapy usually do not require dose adjustment or drug discontinuation, but should lead to a search for other causes of liver disease. There is no evidence to indicate that there is cross sensitivity to liver injury among the various GnRH analogues.

Drug Class: Antineoplastic Agents, GnRH Analogues

Other Drugs in the Subclass, GnRH Analogues: Degarelix, Histrelin, Leuprolide, Relugolix, Triptorelin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Goserelin – Generic, Zoladex®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Goserelin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Goserelin | 65807-02-5 | C59-H84-N18-O14

## ANNOTATED BIBLIOGRAPHY

References updated: 28 May 2023

Abbreviations: FSH, follicle stimulating hormone; GnRH, gonadotropin releasing hormone; LH, luteinizing hormone; PSA, prostate specific antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999; goserelin and other GnRH analogues are not discussed).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal products; does not discuss the GnRH analogues such as goserelin).
Levin ER, Vitek WS, Hammes SR. Estrogens, progestins, and the female reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-31. (Textbook of pharmacology and therapeutics).
Snyder PJ. Androgens and the male reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 833-43. (Textbook of pharmacology and therapeutics).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-47. (Textbook of pharmacology and therapeutics).
Peeling WB. (1989). Phase III studies to compare goserelin (Zoladex) with orchiectomy and with diethylstilbestrol in treatment of prostatic carcinoma. Urology. (In two large multicenter trials comparing goserelin to orchiectomy [358 patients] and goserelin to DES [250 patients], survival was similar with either treatment and goserelin had fewer side effects than DES; no mention of ALT elevations or hepatotoxicity).
Miller RM, Frank RA. (1992). Zoladex (goserelin) in the treatment of benign gynaecological disorders: an overview of safety and efficacy. Br J Obstet Gynaeco. (Review of the efficacy and safety of goserelin in 866 patients with various benign disorders mentions that there were no deaths, no unexpected severe adverse events, and "no clinically relevant effect on the usual biochemical parameters such as urea, electrolytes and liver-function tests").
Maillefert JF, Sibilia J, Kuntz JL, Tavernier C. (1994). Gonadotrophin-releasing hormone agonists induce osteoporosis. Br J Rheumatol. (Two men with prostate cancer, ages 58 and 69 years, were treated with leuprolide for 3 years and triptorelin for 9 months when they presented with back pain and vertebral fractures which were not present on pretreatment imaging).
Vogelzang NJ, Chodak GW, Soloway MS, Block NL, Schellhammer PF, Smith JA, Caplan RJ, et al. (1995). Goserelin versus orchiectomy in the treatment of advanced prostate cancer: final results of a randomized trial. Zoladex Prostate Study Group. Urology. (Among 283 patients with prostate cancer treated with goserelin or orchiectomy, objective responses and survival were the same in the two groups and the toxicity of goserelin "was decidedly minor" and not particularly different from that after surgery; no mention of ALT elevations or hepatotoxicity).
Dijkman GA, Debruyne FM, Fernandez del Moral P, Plasman JW, Hoefakker JW, Idema JG, Sykes M. (1995). A randomised trial comparing the safety and efficacy of the Zoladex 10.8-mg depot, administered every 12 weeks, to that of the Zoladex 3.6-mg depot, administered every 4 weeks, in patients with advanced prostate cancer. Eur Urol. (Comparison safety and efficacy of monthly [3.6 mg] vs 3-monthly [10.8 mg] depot injections of goserelin in 80 patients with advanced prostate cancer found no difference in testosterone responses or side effects).
Debruyne FM, Dijkman GA, Lee DC, Witjes WP, del Moral F, Karthaus HF, van der Mejden AP, et al. (1996). A new long acting formulation of the luteinizing hormone-releasing hormone analogue goserelin: results of studies in prostate cancer. J Urol. (Comparison of goserelin depot subcutaneous injections every 4 weeks [3.6 mg] or every 12 weeks [10.8 mg] found no differences in efficacy or safety; no mention of ALT elevations or hepatotoxicity).
Thorpe SC, Azmatullah S, Fellows GJ, Gingell JC, O'Boyle PJ. (1996). A prospective, randomised study to compare goserelin acetate (Zoladex) versus cyproterone acetate (Cyprostat) versus a combination of the two in the treatment of metastatic prostatic carcinoma. Eur Urol. (Among 525 patients with advanced prostate cancer treated with goserelin, cyproterone or both, the combination had no advantage in prolonging survival, but did reduce side effects of hot flashes; no mention of ALT elevations or hepatotoxicity).
Hands KE, Alvarez A, Bruder JM. (2007). Gonadotropin-releasing hormone agonist-induced pituitary apoplexy in treatment of prostate cancer: case report and review of literature. Endocr Pract. (Review of 7 cases of pituitary apoplexy occurring after initiation of GnRH agonist therapy for prostate cancer).
Guerra Y, Lacuesta E, Marquez F, Raksin PB, Utset M, Fogelfeld L. (2010). Apoplexy in non functioning pituitary adenoma after one dose of leuprolide as treatment for prostate cancer. Pituitary. (60 year old man with prostate cancer developed headaches and neurologic symptoms within 24 hours of a first injection of leuprolide, and subsequent evaluation revealed a previously unsuspected non-functioning pituitary adenoma).
Masuda N, Iwata H, Rai Y, Anan K, Takeuchi T, Kohno N, Takei H, et al. (2011). Monthly versus 3-monthly goserelin acetate treatment in pre-menopausal patients with estrogen receptor-positive early breast cancer. Breast Cancer Res Treat. (Among 170 patients with estrogen receptor positive early breast cancer treated with goserelin every 4 [3.6 mg] or every 12 [10.8 mg] weeks, there were no differences in markers of efficacy, safety or tolerability and no drug related serious adverse events; no mention of ALT elevations).
Duburque C, Bonnal JL, Gosset P, Lucidarme D. (2012). Prog Urol. (59 year old man with prostate cancer and heavy alcohol intake [80 gm daily] developed jaundice 6 weeks after stopping bicalutamide and 10 days after a 2nd every-12-week injection of goserelin [bilirubin 21.3 mg/dL, ALT 50 times ULN, Alk P 2 times ULN, ANA 1:640, MCV 105], resolving 4 months after onset).
Van Poppel H, Klotz L. (2012). Gonadotropin-releasing hormone: an update review of the antagonists versus agonists. Int J Urol. (Review of androgen deprivation therapy for prostate cancer using GnRH agonists and antagonists stressing the more rapid onset of action and similar if not better safety profile of GnRH antagonists).
Walker LM, Tran S, Robinson JW. (2013). Luteinizing hormone--releasing hormone agonists: a quick reference for prevalence rates of potential adverse effects. Clin Genitourin Cancer. (Systematic review of adverse event profile of long term use of GnRH agonists, which mostly relate to the hormonal changes that occur: hot flashes, gynecomastia, genital shrinkage, hair loss, osteoporosis, mild anemia, hyperglycemia, increased weight, loss of skeletal muscle mass, emotional lability, depression, loss of sexual desire and erectile dysfunction; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to goserelin or any of the GnRH analogues).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e.7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to goserelin or any of the GnRH analogues).
Noguchi S, Kim HJ, Jesena A, Parmar V, Sato N, Wang HC, Lokejaroenlarb S, et al. (2016). Phase 3, open-label, randomized study comparing 3-monthly with monthly goserelin in pre-menopausal women with estrogen receptor-positive advanced breast cancer. Breast Cancer. (Among 222 premenopausal women with breast cancer treated with tamoxifen and goserelin [every 1 or 3 months], adverse events included hot flush [17%], headache [6%], back pain [6%], and nausea [5%]; no mention of ALT elevations or hepatotoxicity).
Bolton EM, Lynch TH. (2018). Are all gonadotropin-releasing hormone agonists equivalent for the treatment of prostate cancer? A systematic review. BJU Int. (Systematic review of literature on relative efficacy and safety of different GnRH agonists, indicates that there is little evidence of superiority of any of the four, largely because of lack of adequately powered, controlled studies comparing them; no mention of ALT elevations or hepatotoxicity).
Kim JY, Im SA, Jung KH, Ro J, Sohn J, Kim JH, Park YH, et al. (2018). breast cancer committee of Korean Cancer Study Group (KCSG). Fulvestrant plus goserelin versus anastrozole plus goserelin versus goserelin alone for hormone receptor-positive, HER2-negative tamoxifen-pretreated premenopausal women with recurrent or metastatic breast cancer (KCSG BR10-04): a multicentre, open-label, three-arm, randomised phase II trial (FLAG study). Eur J Cancer. (Among 283 Korean premenopausal women with metastatic breast cancer treated with goserelin alone or combined with either fluvestrant or anastrozole, time to progression was longest with fluvestrant and goserelin, although adverse event rates were similar in all three groups: no mention of ALT levels or hepatotoxicity).
Cornford P, Jefferson K, Cole O, Gilbody J. (2018). Effects of initiating or switching to a six-monthly triptorelin formulation on prostate cancer patient-healthcare interactions and hospital resource use: a real-world, retrospective, non-interventional study. Oncol Ther. (Among 41 adults with advanced prostate cancer who were switched from every 1 or 3 monthly GnRH regimen to 6 monthly triptorelin, healthcare visits, injections and PSA testing were less as were adverse side effects including fatigue [12% vs 26%], urinary frequency [9% vs 32%], and bone pain [7% vs 14%]; no mention of ALT elevations or hepatotoxicity).
Sun Y, Xie L, Xu T, Jakobsen JS, Han W, Sørensen PS, Wang X. (2020). Efficacy and safety of degarelix in patients with prostate cancer: Results from a phase III study in China. Asian J Urol. (Among 283 Chinese men with prostate cancer treated with goserelin or degarelix for 12 months, suppression of serum testosterone to castrate levels was more rapid with degarelix but ultimate rates achieved were similar in both groups, and while total adverse events were fewer with goserelin alone [59% vs 76%], serious adverse event rates were similar in the two groups and there was no mention of ALT levels or hepatotoxicity).
Bahl A, Rajappa S, Rawal S, Bakshi G, Murthy V, Patil K. (2022). A review of clinical evidence to assess differences in efficacy and safety of luteinizing hormone-releasing hormone (LHRH) agonist (goserelin) and LHRH antagonist (degarelix). Indian J Cancer. (Systematic review of studies comparing the efficacy and safety of the 3 GnRH analogues used in therapy of prostate cancer identified 12 studies which showed overall no differences in efficacy in reducing serum testosterone levels and, in 4 studies reporting data on safety, similar degrees of tolerance and rates of adverse events: no mention of ALT elevations or hepatotoxicity).
Lambertini M, Boni L, Michelotti A, Magnolfi E, Cogoni AA, Mosconi AM, Giordano M, et al., GIM study group. (2022). Long-term outcomes with pharmacological ovarian suppression during chemotherapy in premenopausal early breast cancer patients. J Natl Cancer Inst. (Among 281 women with early onset breast cancer treated with chemotherapy with or without a GnRH analogue to preserve ovarian function, disease-free and overall survival were similar in the two groups and those given the GnRH analogue were slightly more likely to have a successful pregnancy during follow up [6.5% vs 3.2%]; no mention of other adverse events, ALT levels or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Goserelin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Goserelin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Goserelin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Goserelin)